# Liver Tumors

Description. Tumors of the liver include benign tumors such as hepatic adenomas, focal nodular hyperplasia, and hemangiomas and malignant cancers such as hepatocellular carcinoma, cholangiocarcinoma, hemangioblastoma, angiosarcoma, hemangioendothelioma, lymphomas and rare mesenchymal tumors. Medications are very rare causes of liver cancers, benign or malignant. Nevertheless, long term estrogenic steroid use has been linked to hepatic adenomas, androgenic steroids to hepatocellular carcinoma, and thorotrast to angiosarcoma of the liver.

Latency to Onset. Liver tumors caused by medications generally arise after years if not decades of use or exposure.

Symptoms. Liver cancers typically present as an abdominal or hepatic mass, found incidentally or because of discomfort or pain. Hepatocellular carcinoma can present with weight loss and malaise, and any of the liver cancers can present with jaundice if they obstruct bile ducts or with sudden onset of severe abdominal pain and hypotension if they cause hepatic rupture. Many tumors, however, are found incidentally after hepatic imaging for another reason reveals a mass.

Serum Enzyme Elevations. Serum enzymes and bilirubin levels are usually normal in patients with hepatic adenomas or focal nodular hyperplasia. Mild and nonspecific abnormalities are present in a small proportion of cases of benign tumors and a larger proportion of cases of liver cancer caused by medications. In cases with biliary obstruction from the mass, the serum alkaline phosphatase can be quite high.

Drugs. Very few medications have been linked to liver tumors. Long term estrogen use, either in the form of oral contraceptives or as postmenopausal replacement, may be associated with development of hepatic adenoma and less commonly with focal nodular hyperplasia (FNH) and hepatocellular carcinoma. Similarly, androgenic steroid use has been linked to development of hepatocellular carcinoma and with rare instances of hepatic adenomas and angiosarcomas. Finally, thorotrast, the radiopaque radiologic dye formerly used in arteriography, has been linked to development of hepatic angiosarcoma.

Differential Diagnosis. The differential diagnosis of a hepatic tumor generally rests upon imaging results, but may require biopsy to fully define. In most instances, the clinical setting will help in the differential diagnosis. For small hepatic masses found incidentally, however, the usual differential diagnosis is hepatic adenoma versus focal nodular hyperplasia, hemangioma, hepatocellular carcinoma or a regenerative nodule.

Criteria for Definition. Elements important in the diagnosis of drug induced liver cancer include the following:

1 Identification of a mass by imaging of the liver
2 Appropriate time of onset in association with starting medication
3 Biological rationale for the association of the cancer with the medications
4 Histological confirmation of the diagnosis of the liver tumor
5 Regression or slowing or lack of further growth upon withdrawal of the implicated agent.

Use of oral contraceptives and estrogenic steroids were first linked to development of liver tumors in the early 1970s. Within a few years, a large number of cases of hepatic adenoma and instances of focal nodular hyperplasia (FHN) had been linked to long term estrogenic steroids use, usually as a part of oral contraceptives. In a small number of instances, malignant transformation of adenomas was found, sections of the tumor mass showing hepatocellular carcinoma. These cases occurred in women taking oral contraceptives who had no other liver disease and otherwise normal liver histology.

Also in the early 1970s, anabolic steroids were implicated in rare cases of hepatocellular carcinoma, usually in the context of aplastic or congenital anemia (Fanconi's anemia, thalassemia) but also in men using anabolic steroids for muscle building. These cancers tended to be less malignant and progressive than hepatocellular carcinoma related to hepatitis B or C. In some instances, there was spontaneous regression once the anabolic steroids were stopped, but others were associated with relentless progression and death from the malignancy. Hepatic adenomas have also been reported in patients on androgenic steroids, but rarely, and they may have represented well differentiated carcinoma. Thus, both estrogens and androgens have been associated with both hepatic adenomas and carcinoma. In large population based studies, however, the link between estrogen use and hepatocellular carcinoma has not been clearly shown; and, similarly, the link between androgenic steroids and adenomas has not been demonstrated.

Angiosarcoma of the liver is a very rare tumor, but a number of cases were linked to previous exposure to the radiocontrast dye known as thorotrast, which had been introduced into medicine in the 1940s and used in arteriography. Between 5 and 30 years after exposure to thorotrast, cases of angiosarcoma (some with thorium dioxide still identifiable in tissue) were described. This tumor is also associated with exposure to vinyl chloride and inorganic arsenic.

## Representative Cases

### Case 1. Hepatic adenoma due to birth control pills.

[Modified from: Steinbrecher UP, Lisbona R, Huang SN, Mishkin S. Complete regression of hepatocellular adenoma after withdrawal of oral contraceptive use. Dig Dis Sci 1981; 26: 1045-50. PubMed Citation]

A 28 year old woman who had been on oral contraceptives (0.25 mg d-norgestrel and 0.05 mg ethinyl estradiol: Ovral) for 7 years presented with dull but steady right upper quadrant pain lasting for two days. She had no other significant medical problems and took no medications except occasional aspirin. She rarely drank alcohol and had no risk factors for viral hepatitis or liver disease. Physical examination revealed an obvious mass in the epigastrium and right upper quadrant that appeared to be associated with the liver. There was no tenderness, ascites, wasting or jaundice. Laboratory results showed an alkaline phosphatase of 1038 U/L, but normal bilirubin and ALT. The sedimentation rate was 59 mm/hr and hemoglobin 10.4 g/dL. A technitium colloid liver-spleen scan showed a large liver but no obvious masses, whereas a HIDA scan showed a large hypofunctioning mass in the liver. A liver biopsy showed hepatic adenoma with sinusoidal dilatation. A hepatic arteriogram showed a large vascular tumor occupying most of the right and central lobes. Resection was not considered technically possible. Oral contraceptives were stopped and she underwent tubal ligation. During the ensuing 12 months, she remained well and repeat scans showed return of liver to normal size. Alkaline phosphatase also fell to normal.

#### Key Points

Medication: | Oral contraceptives for 7 years
Pattern: | Alkaline phosphatase elevation only
Latency: | 7 years
Recovery: | Radiological resolution over 12 months
Other medications: | Aspirin

#### Comment

Hepatic adenomas are a rare, but well defined complication of long term use of oral contraceptives. They can present in three manners: (1) with sudden acute right upper quadrant pain and rupture, (2) as an abdominal mass with or without mild degrees of pain, or (3) as an incidental finding on physical examination, during unrelated abdominal surgery or on routine radiological imaging. The association of contraceptive use and hepatic adenomas has been made both epidemiologically and clinically, the clinical evidence being supported by the rarity of this tumor before the introduction of oral contraceptives and the spontaneous resolution or shrinkage of the tumors upon withdrawal of the pill, as in this case. Serum alkaline phosphatase levels are raised in some, but certainly not all women with this tumor and liver tests are typically normal. In this instance, the high alkaline phosphatase levels were probably related to the size of the tumor and its encroachment on the normal liver and biliary system. This case also demonstrates that the tumor can be managed by stopping the oral contraceptives and careful follow up. In rare instances, hepatic adenomas have later been found to show malignant transformation. There is likely a genetic basis to the development of hepatic adenomas on oral contraceptives.

## Selected References

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Expert review of effects of estrogens, birth control pills and androgenic steroids on the liver published in 1999; both estrogens and androgens have been associated with cholestatic liver injury as well as liver tumors; estrogens with hepatic adenomas and androgens with hepatocellular carcinoma).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 707-22. (Review of hepatotoxicity of oral contraceptive and androgenic steroids published in 2007; both forms of sex hormones can cause cholestasis, vascular disorders, benign tumors and hepatocellular carcinoma).
Johnson FL, Feagler JR, Lerner KG, Majerus PW, Siegel M, Hartmann JR, Thomas ED. (1972). Association of androgenic-anabolic steroid therapy with the development of hepatocellular carcinoma. Lancet. (Description of 4 cases of hepatocellular carcinoma related to C17-alkylated anabolic steroids given for aplastic anemia or Fanconi syndrome, ages 5-27 years taking drugs for 1-7 years; regression of tumor in one with withdrawal; all died within one year).
Baum JK, Brookstein JJ, Holtz F, Klein EW. (1973). Possible association between benign hepatomas and oral contraceptives. Lancet. (Seven cases of hepatic adenoma in woman on oral contraceptives [OCCs] for 0.5 to 7 years, ages 25 to 39 years, 5 with rupture, one fatal).
Mays ET, Christopherson WM, Burrows GH. (1974). Focal nodular hyperplasia of the liver . possible relationship to oral contraceptives. Am J Clin Pathol. (Three women on OCCs for 4 to 7 years found to have large hepatic masses after presenting with pain or hemoperitoneum; appeared to be focal nodular hyperplasia rather than adenomas).
Farrell GC, Joshua DE, Uren RF, Baird PJ, Perkins KW. (1975). Kronenberg. Androgen-induced hepatoma. Lancet. (Three cases of hepatocellular carcinoma in men on androgenic steroids, ages 28 to 40 years, on oxymetholone or methyltestosterone for 5 to 8 years, liver and tumor size decreasing on stopping androgenic steroids).
Edmondson HA, Reynolds TB, Henderson B, Benton B. (1976). Liver cell adenomas associated with use of oral contraceptives. N Engl J Med. (Analysis of 42 women with hepatic adenomas and matched controls; OCC use was common [85% vs 70%] and used for longer in those with adenomas [80 vs 38 months] and higher mestranol vs ethinyl estradiol use).
Mays ET, Christopherson WM, Mahr MM, Williams HC. (1976). Hepatic changes in young women ingesting contraceptive steroids: hepatic hemorrhage and primary tumors. JAMA. (Review of 13 women presenting with liver tumors on OCCs seen between 1968-74; none had cirrhosis; 9 tumors were benign [mostly focal nodular hyperplasia; all alive] and 4 malignant [hepatocellular carcinoma; 3 died]; 6 presented with rupture, one tumor recurred in woman who continued OCC use).
Rooks JB, Ory HW, Ishak KG, Straus LT, Greenspan JR, Hill AP, Tyler CW, Cooperative Liver Tumor Study Group. (1979). Epidemiology of hepatocellular adenoma. The role of oral contraceptive use. JAMA. (Case control study of 79 young women with hepatic adenomas from the files of the Armed Forces Institute of Pathology compared to 299 controls, found increasing relative risk with long term OCC use from 1 if <12 months to 129 for greater than 5 years; rate estimate of 3.4/100,000 patient years).
Stromeyer FW, Smith DH, Ishak KG. (1979). Anabolic steroid therapy and intrahepatic cholangiocarcinoma. Cancer. (47 year old man developed hepatic tumor and progressive hepatic failure 2 years after starting therapy with oxymetholone therapy for refractory anemia; autopsy showed cholangiocarcinoma).
Ishak KG. (1981). Hepatic lesions caused by anabolic and contraceptive steroids. Semin Liver Dis. (Review of effects of male and female sex hormones on the liver including biochemical changes, subcellular alternations, cholestasis, vascular disorders, hyperplasia, neoplasia and miscellaneous).
Falk H, Herbert J, Crowley S, Ishak KG, Thomas LB, Popper H, Caldwell GG. (1981). Epidemiology of hepatic angiosarcoma in the United States: 1964-1974. Environ Health Perspect. (Survey for angiosarcoma in the US from 1964 to 1974 found 168 cases, 42 with a known risk factor including thorotrast [20], vinyl chloride [12], arsenic [6] and androgenic steroids [4]).
Malt RA, Galdabini JJ, Jeppsson BW. (1983). Abnormal sex-steroid milieu in young adults with hepatocellular carcinoma. World J Surg. (Among 7 patients, ages 20-30 years, with hepatocellular carcinoma seen over 15 year period, 2 were men on methyltestosterone in whom the tumor regressed on stopping androgens and they were alive 2 and 7 years later).
Pelletier G, Frija J, Szekely AM, Clauvel JP. (1984). Adenoma of the liver in man. Gastroenterol Clin Biol. (26 year old man with solitary hepatic adenoma; review of literature found only 31 cases of adenomas in men, 8 of whom had received anabolic steroids).
Stanford JL, Thomas DB. (1992). The WHO Collaborative Study of Neoplasia and Steroid Contraceptives. Reproductive factors in the etiology of hepatocellular carcinoma. Cancer Causes and Control. (Results from hospital based case control study in 4 developing countries of 83 patients with hepatocellular carcinoma [HCC] vs 596 controls found having multiple full term pregnancies but not use of OCCs was associated with HCC).
Ferrell L. (1993). Hepatocellular carcinoma arising in a focus of multilobular adenoma. A case report. Am J Surg Pathol. (29 year old woman with abdominal pain, hepatic mass and Alk P >2000 U/L, found to have an 18 cm hepatic adenoma within which was a 5 cm hepatocellular carcinoma; the tumor was resected and the patient was without evidence of recurrence 4 years later).
Waetjen LE, Grimes DA. (1996). Oral contraceptives and primary liver cancer: temporal trends in three countries. Obstet Gynecol. (Analysis of primary liver cancer deaths from US, Japan and Sweden with several hundred million woman-years of exposures to OCCs found no support for role of OCCs in causing hepatocellular carcinoma).
Makhlouf HR, Ishak KG, Goodman ZD. (1999). Epithelioid hemangioendothelioma of the liver: a clinicopathologic study of 137 cases. Cancer. (Analysis of 137 cases of epithelioid hemangioendothelioma from the Armed Forces Institute of Pathology; mean age 47 years, 61% women; incidental finding in 42%, symptoms if present usually pain, ~50% 5 year survival, little information on OCCs but unlikely to be important).
Bork K, Pitton M, Harten P, Koch P. (1999). Hepatocellular adenomas in patients taking danazol for hereditary angio-oedema. Lancet. (Among 87 patients with hereditary angioneurotic edema, 41 were treated with danazol, 11 for more than 10 years, 3 of whom developed hepatocellular adenomas at ages 29, 39 and 67 which were resected and did not show carcinoma).
Gemer O, Moscovici O, Ben-Horin CL, Linov L, Peled R, Segal S. (2004). Oral contraceptives and liver hemangioma: a case-control study. Acta Obstet Gynecol Scand. (Case control study of 40 women with liver hemangiomas and 109 controls; OCC use in 30% vs 27%).
Maheshwari S, Sarraj A, Kramer J, El-Serag HB. (2007). Oral contraception and the risk of hepatocellular carcinoma. J Hepatol. (Meta analysis of studies on OCCs and hepatocellular carcinoma; 12 case control studies, pooled estimate of odds ratio of 1.57, but overall the evidence "is inconclusive").

## Hepatic Histology

[Under Construction]